# Alpha 1 Adrenergic Receptor Antagonists

## OVERVIEW

The alpha-1 adrenergic receptor antagonists (also called alpha-blockers) are a family of agents that bind to and inhibit type 1 alpha-adrenergic receptors and thus inhibit smooth muscle contraction. Their major uses are for hypertension and for symptomatic benign prostatic hypertrophy. Their use in therapy of hypertension is based on the inhibition of vascular resistance in arterioles from alpha-adrenergic blockade, which results in an increase in venous capacitance and lowering of blood pressure. At present, however, the alpha-1 adrenergic antagonists are recommended only as adjunctive therapy of hypertension and not as monotherapy. Postural hypotension is particularly common after the initial dose of the alpha-1 adrenergic antagonist. Also, long term therapy has not been associated with improvement in survival; indeed at least one study has shown an increase in heart failure, stroke and cardiovascular disease with long term therapy with alpha-blockers. Because the nonselective alpha-1 adrenergic antagonists cause a relaxation of smooth muscle both in arterioles (alpha-1b receptors) and in the bladder neck and prostate (alpha-1a receptors), they are also useful in the therapy of symptoms of urinary obstruction due to benign prostatic hypertrophy. Recently, selective alpha-1a adrenergic receptors blockers have been developed for use in benign prostatic hypertrophy that are claimed to have less effect on blood pressure. Thus, only the nonselective agents are used for treatment of hypertension, whereas both selective and nonselective agents have been used for the symptomatic relief of prostatic hypertrophy.

The nonselective alpha-1 adrenergic antagonists in clinical use for hypertension in the United States include three agents of similar chemical structure (piperazinyl quinazolines) and activity, but somewhat different potencies and pharmacokinetics: prazosin (Minipress: 1976), terazosin (Hytrin: 1987), and doxazosin (Cardura: 1990). These agents, which are used in the treatment of hypertension, are discussed elsewhere.

The alpha-1 adrenergic antagonists in clinical use for benign prostatic hypertrophy and symptoms of urinary hesitancy in the United States include three nonselective agents – terazosin and doxazosin (see Antihypertensive Agents drug records) and alfuzosin (Uroxatral: 2003), and two selective alpha-1a adrenergic receptor antagonists – tamsulosin (Flomax: 2007) and silodosin (Rapaflo: 2008). The selective agents have the potential of reducing bladder neck tone with less risk of hypotension.

All of the alpha-1 adrenergic receptor antagonists are associated with a minimal rate of serum enzyme elevations during chronic therapy (0.2% to 2%). These elevations are almost always mild-to-moderate in severity, self-limited, and do not require dose modification or drug discontinuation. As a class, the alpha-1 adrenergic antagonists have been associated with rare instances of clinically apparent acute liver injury, but reported cases have been self-limiting and not associated with acute liver failure or chronic liver injury. Alfuzosin has been linked to the most reported cases, and several of the alpha-1 adrenergic antagonists have not been linked to any cases in the literature. Thus, clinically apparent liver injury from these agents is uncommon and severe hepatotoxicity is exceeding rare, if it occurs at all.

The alpha-1 adrenergic antagonists are discussed individually, but the references on their safety and hepatotoxicity are given together after this introductory section.

Alpha-blockers used to treat hypertension:

- Doxazosin
- Prazosin
- Terazosin
- Antihypertensive Agents

Alpha-blockers used to treat benign prostatic hypertrophy (BPH):

- Alfuzosin
- Doxazosin
- Silodosin
- Tamsulosin
- Terazosin
- Benign Prostatic Hypertrophy Agents

## ANNOTATED BIBLIOGRAPHY

References updated: 08 January 2018

Zimmerman HJ. Cardiovascular agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; mentions that alpha-adrenergic blocking agents [prazosin] have little identified involvement in hepatic injury).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of antihypertensive agents does not discuss alpha-adrenergic receptor blockers).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics mentions that the alpha-1 receptor antagonists are used primarily in conjunction with diuretics, beta-blockers or other antihypertensive agents).
Westfall TC, Westfall DP. Adrenergic agonists and antagonists. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 277-334. (Textbook of pharmacology and therapeutics mentions that the clinical response to alph-adrenergic blockade is dictated not only by their direct effects but also by the reflex homeostatic adjustments to these initial effects).
Sperzel WD, Glassman HN, Jordan DC, Luther RR. Overall safety of terazosin as an antihypertensive agent. Am J Med 1986; 80: 77-81. (Evaluation of safety of terazosin in 1006 hypertensive patients discusses clinical laboratory test results, but makes no mention of liver test abnormalities or ALT elevations). 2872812
Frick MH, Halttunen P, Himanen P, Huttunen M, Pörsti P, Pitkäjärvi T, Pöyhönen L, et al. A long-term double-blind comparison of doxazosin and atenolol in patients with mild to moderate essential hypertension. Br J Clin Pharmacol 1986; 21 Suppl 1: 55S-62S. (Controlled trial of doxazosin vs atenolol in 143 patients with hypertension; "No significant trend emerged in either of the treatment groups with respect to laboratory abnormalities"). 2939868
Torvik D, Madsbu HP. An open one-year comparison of doxazosin and prazosin for mild to moderate essential hypertension. Am J Cardiol 1987; 59: 68G-72G. (Open label comparison of doxazosin and prazosin in 104 patients with hypertension for 3-15 months; 14% developed "minor, clinically unimportant ... biochemical abnormalities"). 2884855
Titmarsh S, Monk JP. Terazosin. A review of its pharmacodynamic and pharmacokinetic properties, and therapeutic efficacy in essential hypertension. Drugs 1987; 33: 461-77. (Review of chemistry, pharmacology, mechanism of action, efficacy and safety of terazosin; among 1006 patients taking terazosin in clinical studies, 14% withdrew because of side effects but none due to liver injury, and laboratory indices "were not significantly altered by terazosin"). 2885169
Soltero I, Guevara J, Silva H, Velasco M. A multicenter study of doxazosin in the treatment of severe essential hypertension. Am Heart J 1988; 116 (6 Pt 2): 1767-71. (Open label study of doxazosin in 33 patients with severe hypertension; no serious adverse events and no abnormal laboratory tests were identified). 2904748
Young RA, Brogden RN. Doxazosin. A review of its pharmacodynamic and pharmacokinetic properties, and therapeutic efficacy in mild or moderate hypertension. Drugs 1988; 35: 525-41. (Review of chemistry, pharmacology, clinical efficacy and side effects of doxazosin; common side effects are dizziness, postural hypotension, fatigue, headache, edema, sexual dysfunction and anxiety; no mention of liver injury or ALT elevations). 2899495
Doxazosin for treatment of hypertension. Med Lett Drugs Ther 1991; 33: 15-6. (Review of doxazosin soon after its approval in the United States; doxazosin has more effect on standing than supine blood pressure and side effects include dizziness, syncope, sexual dysfunction and nervousness; no mention of liver toxicity or ALT elevations). 1825232
Achari R, Laddu A. Terazosin: a new alpha adrenoceptor blocking drug. J Clin Pharmacol 1992; 32: 520-3. (Review of pharmacology, metabolism, clinical efficacy and safety of terazosin; "Terazosin does not produce significant changes in clinical laboratory variables"). 1353083
Itskovitz HD. Alpha 1-blockade for the treatment of hypertension: a megastudy of terazosin in 2214 clinical practice settings. Clin Ther 1994; 16: 490-504. (Analysis of efficacy and safety of terazosin in 16,917 patients followed at 2214 clinical sites; 14% of patients stopped therapy because of side effects, but none for liver disease and no mention of ALT elevations or hepatotoxicity). 7923316
Lepor H, Williford WO, Barry MJ, Brawer MK, Dixon CM, Gormley G, Haakenson C, et al. The efficacy of terazosin, finasteride, or both in benign prostatic hyperplasia. Veterans Affairs Cooperative Studies Benign Prostatic Hyperplasia Study Group. N Engl J Med 1996; 335: 533-9. (Among 1229 men with prostatic hypertrophy treated with placebo, terazosin, finasteride or both, side effects of terazosin included dizziness [26%], fatigue [14%], impotence [6%] and headache [6%]; "There were no clinically or statistically significant changes in hematologic or blood chemical values in any treatment group"). 8684407
McKiernan JM, Lowe FC. Side effects of terazosin in the treatment of symptomatic benign prostatic hyperplasia. South Med J 1997; 90: 509-13. (Analysis of side effects of terazosin from 7 controlled trials in 3,080 patients; dizziness [11%], postural hypotension [2.7%], fatigue [7.5%], peripheral edema [2.8%] and drowsiness [2.4%]; no mention of hepatotoxicity or ALT elevations). 9160069
Tamsulosin for benign prostatic hyperplasia. Med Lett Drugs Ther 1997; 39: 96. (Brief summary of efficacy and safety of tamsulosin for benign prostatic hypertrophy; no mention of hepatotoxicity or ALT elevations). 9379999
Hernández-Cano N, Herranz P, Lázaro TE, Mayor M, Casado M. Severe cutaneous reaction due to terazosin. Lancet 1998; 352: 202-3. (56 year old man developed fever and pruritic rash 3 days after starting terazosin with resolution within 2 weeks on corticosteroid therapy; liver tests were normal). 9683215
Zabala S, Thomson C, Valdearcos S, Gascón A, Pina MA. Alfuzosin-induced hepatotoxicity. J Clin Pharm Ther 2000; 25: 73-4. (63 year old man developed jaundice 9 months after starting alfuzosin [bilirubin 24.3 mg/dL, ALT 2711 U/L, Alk P 500 U/L], with slow resolution [6 months] after stopping). 10771467
Roehrborn CG. Alfuzosin: overview of pharmacokinetics, safety, and efficacy of a clinically uroselective alpha-blocker. Urology 2001; 58(6 Suppl 1): 55-63. (Review of pharmacology, clinical efficacy and safety of alfuzosin for benign prostatic hypertrophy; side effects include dizziness, fatigue and nasal stuffiness; no mention of ALT measurements or hepatotoxicity). 11750253
Fernández Salazar L, Palencia García A. [Hepatotoxicity induced by terazosin]. Med Clin(Barc) 2003; 120: 118. Spanish. (53 year old man with renal disease developed serum enzyme elevations without symptoms 3 months after starting terazosin for prostatic hypertrophy [bilirubin normal, ALT 290 U/L, Alk P 560 U/L], aminotransferase levels falling to normal within a month of stopping). 12605736
Yolcu OF, Köklu S, Köksal AS, Yüksel O, Beyazit Y, Basar O. Alfuzosin-induced acute hepatitis in a patient with chronic liver disease. Ann Pharmacother 2004; 38: 1443-5. (80 year old man with known chronic hepatitis B developed jaundice within 2 weeks of starting alfuzosin [bilirubin 35.1 mg/dL, AST 917 U/L, Alk P 260 U/L, HBV DNA negative], resolving within 3 months of stopping alfuzosin). 15280514
Alfuzosin (uroxatral) - another alpha1-blocker for benign prostatic hyperplasia. Med Lett Drugs Ther 2004; 46: 1-2. (Review of alfuzosin as therapy of benign prostatic hypertrophy soon after its approval in the US; appears to cause less hypotension than doxazosin and terazosin and less ejaculatory dysfunction than tamsulosin; no mention of hepatotoxicity). 14691408
Fremond L, Diebold MD, Thiefin G. [Acute pseudoangiocholitic hepatitis probably induced by tamsulosin]. Gastroenterol Clin Biol 2006; 30: 1224-5. French. (65 year old man developed jaundice, abdominal pain and fever 11 days after starting tamsulosin [bilirubin 7.4 mg/dL, ALT 9 times ULN, Alk P normal], resolving 5 weeks after stopping). 17075484
Kim SY, Kim BH, Dong SH, Kim HJ, Chang YW, Chang R, Kim YW. Alfuzosin-induced acute liver injury. Korean J Hepatol 2007; 13: 414-8. (56 year old man developed jaundice one month after starting alfuzosin [bilirubin 7.6 rising to 25 mg/dL, ALT 1088 U/L, Alk P 167 U/L, eosinophils 8%, high IgE levels]; prolonged jaundice resolving 5 months after stopping). 17898558
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none of the cases were attributed to alpha-1 adrenergic blocking agents). 18955056
Drugs for hypertension. Treat Guidel Med Lett 2009; 7: 1-10. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; side effects of alpha-1 adrenergic blockers include syncope, dizziness, headache, palpitations, fluid retention, drowsiness, weakness, priapism, thrombocytopenia and atrial fibrillation; no mention of liver injury or ALT elevations). 19107095
Silodosin (Rapaflo) for benign prostatic hyperplasia. Med Lett Drugs Ther 2009; 51: 3-4. (Brief review of silodosin soon after its approval by the FDA; no mention of hepatotoxicity). 19122568
Cantrell MA, Bream-Rouwenhorst HR, Hemerson P, Magera JS Jr. Silodosin for benign prostatic hyperplasia. Ann Pharmacother 2010; 44: 302-10. (Review of pharmacology, clinical efficacy and safety of silodosin as therapy of benign prostatic hypertrophy; no discussion of ALT elevations or hepatotoxicity but silodosin is extensively metabolized by the liver, largely via CYP 3A4, and "In postmarketing reports, toxic skin eruptions, purpura, jaundice and increase transaminase values have been reported"). 20071497
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury of which 2 were attributed to antihypertensive agents [hydralazine and methyldopa], but none to an alpha-adrenergic receptor blocker). 20949552
Titos-Arcos JC, Hallal H, Andrade RJ, López Martín A. [Recurrent hepatocellular lesion due to alfuzosin]. Gastroenterol Hepatol 2011; 34: 125-7. Spanish. (55 year old man developed ALT elevations 10 months after starting alfuzosin [ALT 109 U/L], resolving upon stopping and recurring with restarting). 21333390
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antihypertensive medications or an alpha-blocker).23419359
Yoshimura K, Kadoyama K, Sakaeda T, Sugino Y, Ogawa O, Okuno Y. A survey of the FAERS database concerning the adverse event profiles of α1-adrenoreceptor blockers for lower urinary tract symptoms. Int J Med Sci 2013; 10: 864-9. (Review of spontaneous reports of adverse events for alpha-1 adrenergic blockers between 1997 and 2011 identified 1,260,182 reports, mostly for dizziness, orthostatic hypotension, erective dysfunction, thirst, dry mouth and constipation; no mention of ALT elevations or hepatotoxicity). 23781132
Yuan J, Liu Y, Yang Z, Qin X, Yang K, Mao C. The efficacy and safety of alpha-1 blockers for benign prostatic hyperplasia: an overview of 15 systematic reviews. Curr Med Res Opin 2013; 29: 279-87. (Systematic review of systematic reviews of safety of alpha blockers for BPH concludes that these agents are more effective than placebo, but have more side effects; no mention of ALT elevations or hepatotoxicity). 23323875
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, no case was attributed to an alpha-1 adrenergic blocker). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, alfuzosin was considered the cause of one case of self-limited cholestatic hepatitis, but no other alpha-1 adrenergic blocker was mentioned). 25754159
Cicek T, Gokturk HS, Unler GK. Acute hepatocellular drug induced liver injury probably by alfuzosin. Case Rep Urol 2015; 2015: 101062. (65 year old man developed fatigue followed by itching and jaundice 9 days after starting alfuzosin [bilirubin 7.6 mg/dL, ALT 402 U/L, Alk P 235 U/L], resolving after stopping). 25793140
Yuan JQ, Mao C, Wong SY, Yang ZY, Fu XH, Dai XY, Tang JL. Comparative effectiveness and safety of monodrug therapies for lower urinary tract symptoms associated with benign prostatic hyperplasia: a network meta-analysis. Medicine (Baltimore) 2015; 94: e974. (Metanalysis of trials of efficacy and safety of single agents used for relief of symptoms of benign prostatic hypertrophy [including doxazosin, terazosin, alfuzosin and tamsulosin]; authors concluded that "drug therapies were typically safe"; no mention of ALT elevations or hepatotoxicity). 26166130
El Said NO, El Wakeel L, Kamal KM, Morad Ael R. Alfuzosin treatment improves the rate and time for stone expulsion in patients with distal uretral stones: a prospective randomized controlled study. Pharmacotherapy 2015; 35: 470-6. (Among 54 patients with a retained distal uretral stone treated with alfuzosin or stardard care, stone expulsion was more frequent with alfuzosin and side effects were tolerable and included headache, dizziness and postural hypotension; no mention of ALT elevations or hepatotoxicity). 26011140